# Edoxaban

## OVERVIEW

### Introduction

Edoxaban is an oral, small molecule inhibitor of factor Xa which is used as an anticoagulant to decrease the risk of venous thromboses, systemic embolization and stroke in patients with atrial fibrillation, and as treatment of deep vein thrombosis and pulmonary embolism. Edoxaban has been linked to a low rate of serum aminotransferase elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Edoxaban (e dox' a ban) is a selective inhibitor of the coagulation factor Xa, the last and rate controlling step in the generation of thrombin, the final intermediate in blood coagulation. Inhibiting thrombin prevents the conversion of fibrinogen to fibrin and subsequent cross linking of fibrin monomers, platelet activation and amplification of coagulation activation. Edoxaban has been shown to be as effective an anticoagulant as warfarin in preventing stroke and systemic embolization in patients with atrial fibrillation. Clinical trials have also shown that edoxaban can decrease the risk of complications of deep vein thrombosis and pulmonary embolism. Edoxaban was approved for use in the United States in 2015, the third direct factor Xa inhibitor to be approved. Current indications are for prevention of stroke and systemic embolism in patients with nonvalvular atrial fibrillation and for treatment of patients with deep vein thrombosis and pulmonary embolism. Edoxaban is not recommended in patients with a creatinine clearance of greater than 95 cc/minute as such patients had increases in ischemic strokes compare to patients treated with warfarin. Edoxaban is available in 15, 30 and 60 mg tablets under the commercial name Savaysa. The usual dose is 60 mg daily. Unlike warfarin, edoxaban and the other oral direct thrombin and factor Xa inhibitors do not require monitoring of bleeding time or INR and rarely require dose adjustments. Side effects are not common, but can include bleeding, headache, gastrointestinal upset, and rash. Rare, but potential severe adverse reactions include major bleeding including hemorrhagic stroke as well as spinal or epidural hematomas, and increased risk of ischemic events in patients with premature discontinuation.

### Hepatotoxicity

Edoxaban is associated with serum aminotransferase elevations greater than 3 times the upper limit of normal in 2% to 5% of treated patients. This rate is similar or lower than rates with warfarin or comparator arms. The elevations are generally transient and not associated with symptoms or jaundice. In premarketing studies, no instances of clinically apparent liver injury were reported, but there was little experience in large numbers of patients treated for extend periods of time. In large health care databases, the rate of liver injury has been somewhat less with edoxaban than rivaroxaban and apixaban, but the numbers of patients treated with edoxaban has been limited and the nature of the liver injury not described.

Likelihood score: D (possible race cause of clinically apparent liver injury).

### Mechanism of Injury

Edoxaban is eliminated largely unchanged in the urine and has minimal hepatic metabolism. It is a substrate of P-glycoprotein, and its serum concentrations can be affected by inducers (rifampin) and inhibitors of this transport protein. The cause of the serum enzyme elevations during therapy with edoxaban is unknown, but the rate of such elevations was usually lower or no different than with comparator anticoagulants.

### Outcome and Management

The serum enzyme elevations during edoxaban therapy have been mild-to-moderate in severity, but asymptomatic and rapidly reversible often even without stopping therapy. Clinically apparent liver injury due to edoxaban appears to be rare and has not been well documented. There is no reason to suspect that there is cross sensitivity to hepatic injury among the various anticoagulants including other factor Xa inhibitors.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants, Newer Direct Oral Anticoagulants: Apixaban, Betrixaban, Fondaparinux, Rivaroxaban

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Edoxaban – Savaysa®

DRUG CLASS

Anticoagulants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Edoxaban)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Edoxaban | 480449-70-5 | C24-H30-Cl-N7-O4-S | SID:135263753

## ANNOTATED BIBLIOGRAPHY

References updated: 16 February 2023

Zimmerman HJ. Antithrombotic agents. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-42. (Textbook of hepatotoxicity published in 1999, well before the availability of edoxaban and the direct factor Xa inhibitors).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 519-53. (Review of hepatotoxicity of cardiovascular drugs does not discuss the anticoagulants).
Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to anticoagulants).
Weitz JI, Connolly SJ, Patel I, Salazar D, Rohatagi S, Mendell J, Kastrissios H, et al. (2010). Randomised, parallel-group, multicentre, multinational phase 2 study comparing edoxaban, an oral factor Xa inhibitor, with warfarin for stroke prevention in patients with atrial fibrillation. Thromb Haemost. (Among 1,146 patients with atrial fibrillation and risk of stroke who were treated with edoxaban [varying regimens] or warfarin for 3 months, rates of stroke were similar in all groups and ALT elevations occurred in 15 of 866 [1.7%] on edoxaban and 4 of 245 [1.6%] on warfarin; concurrent ALT, Alk P and bilirubin elevations in 2 edoxaban treated subjects were attributed to other conditions [gallstones and heart failure]).
Raskob G, Cohen AT, Eriksson BI, Puskas D, Shi M, Bocanegra T, Weitz JI. (2010). Oral direct factor Xa inhibition with edoxaban for thromboprophylaxis after elective total hip replacement. A randomised double-blind dose-response study. Thromb Haemost. (Among 903 patients undergoing hip replacement who received either edoxaban [15, 30, 60 or 90 mg daily] or dalteparin for 7 to 10 days, rates of venous thromboembolism was less with edoxaban [11-20%] than dalteparin [44%], while rates of ALT elevations above 3 times ULN were similar [2.4-4.3% vs 2.9%]).
(2010). Treatment of atrial fibrillation. Treat Guidel Med Lett. (Concise review of treatment of atrial fibrillation including use of apixaban and rivaroxaban; does not mention hepatotoxicity or ALT elevations).
Hokusai-VTE Investigators. (2013). Edoxaban versus warfarin for the treatment of symptomatic venous thromboembolism. N Engl J Med. (Among 4921 patients with deep venous thrombosis and 3319 with pulmonary embolism treated with edoxaban [30 or 60 mg daily] of warfarin for 3 to 12 months, recurrent thromboembolism was similar with either agent [3.2% vs 3.5%], as were adverse events with ALT elevations above 3 times ULN in 2.1% vs 2.3%, concurrent ALT and bilirubin elevations in 0.2% vs 0.1%, and no instance of a serious hepatic adverse event).
Fuji T, Wang CJ, Fujita S, Kawai Y, Nakamura M, Kimura T, Ibusuki K, et al. (2014). Safety and efficacy of edoxaban, an oral factor Xa inhibitor, versus enoxaparin for thromboprophylaxis after total knee arthroplasty: the STARS E-3 trial. Thromb Res. (Among 594 patients undergoing hip replacement treated with either edoxaban or enoxaparin for 11-14 days, thromboembolism occurred in 7% vs 14%, while ALT elevations above 3 times ULN occurred in 0.6% vs 6%).
(2014). New oral anticoagulants for acute venous thromboembolism. Med Lett Drugs Ther. (Brief comparison of warfarin, rivaroxaban, apixaban and dabigatran as anticoagulants for therapy of venous thromboembolism, all of which have similar efficacy, warfarin requiring regular monitoring of INR whereas the others do not).
Caldeira D, Barra M, Santos AT, de Abreu D, Pinto FJ, Ferreira JJ, Costa J. (2014). Risk of drug-induced liver injury with the new oral anticoagulants: systematic review and meta-analysis. Heart. (Systematic review of 29 controlled trials of oral anticoagulants in 152,116 patients focusing on risk of drug induced liver injury [including 1 trial with 3878 patients on edoxaban] found no increase in rate of serum ALT or AST elevations above 3 times ULN [2.1% vs 2.3%] or combined enzyme and bilirubin elevations above 2 times ULN [0.2% vs 0.08%] with edoxaban therapy compared to control patients on warfarin, and concludes that the direct Factor Xa inhibitors "do not increase the risk of DILI").
Fuji T, Fujita S, Kawai Y, Nakamura M, Kimura T, Fukuzawa M, Abe K, Tachibana S. (2015). Efficacy and safety of edoxaban versus enoxaparin for the prevention of venous thromboembolism following total hip arthroplasty: STARS J-V. Thromb J. (Among 610 patients undergoing hip replacement who were treated with edoxaban [30 mg daily] or enoxaparin [subcutaneously twice daily] for 11-14 days, venous thromboembolism events occurred in 2.4% vs 6.9% with no increase in bleeding episodes, and ALT elevations in 12% vs 42%, being above 3 times ULN in 3.3% vs 13.7%).
Liakoni E, Rätz Bravo AE, Krähenbühl S. (2015). Hepatotoxicity of new oral anticoagulants (NOACs). Drug Saf. (Review of published literature and data from pharmacovigilance registries on liver injury due to new oral anticoagulants including edoxaban, apixaban and rivaroxaban concludes that hepatotoxicity is possible with these agents, but is rare and does not warrant routine monitoring).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, two were attributed to antithrombotic agents [prasugrel and dalteparin], but none to edoxaban or other direct factor Xa inhibitors).
(2015). Edoxaban (Savaysa)--the fourth new oral anticoagulant. Med Lett Drugs Ther. (Concise review of efficacy and safety of edoxaban for prevention of stroke or systemic embolization in patients with nonvalvular atrial fibrillation, which is equivalent or better in efficacy than warfarin with a lower rate of bleeding; no mention of hepatotoxicity or ALT elevations).
Kawai Y, Fuji T, Fujita S, Kimura T, Ibusuki K, Abe K, Tachibana S. (2016). Edoxaban versus enoxaparin for the prevention of venous thromboembolism after total knee or hip arthroplasty: pooled analysis of coagulation biomarkers and primary efficacy and safety endpoints from two phase 3 trials. Thromb J. (Among 716 patients undergoing total knee replacement in two trials in Asia comparing edoxaban to enoxaparin given for 11-14 days, thromboembolic events were less common with edoxaban [5% vs 11] while bleeding and other adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Goette A, Merino JL, Ezekowitz MD, Zamoryakhin D, Melino M, Jin J, Mercuri MF, et al., ENSURE-AF investigators. (2016). Edoxaban versus enoxaparin-warfarin in patients undergoing cardioversion of atrial fibrillation (ENSURE-AF): a randomised, open-label, phase 3b trial. Lancet. (Among 2199 patients with atrial fibrillation undergoing cardioversion treated with edoxaban or enoxaparin-warfarin, major thrombotic events were rare [<1% vs 1%] as were major bleeding episodes [<1% vs <1%] and overall adverse event rates [30% vs 33%]; no mention of ALT elevations or hepatotoxicity).
Conway SE, Hwang AY, Ponte CD, Gums JG. (2017). Laboratory and clinical monitoring of direct acting oral anticoagulants: What clinicians need to know. Pharmacotherapy. (Review and recommendations largely on use of coagulation tests to monitor oral anticoagulant therapy, but also concludes: "Hepatic function in otherwise healthy individuals can be assessed yearly or more frequently in those with hepatic impairment").
Alonso A, MacLehose RF, Chen LY, Bengtson LG, Chamberlain AM, Norby FL, Lutsey PL. (2017). Prospective study of oral anticoagulants and risk of liver injury in patients with atrial fibrillation. Heart. (Analysis of a database on more than 1 million patients with nonvalvular atrial fibrillation on oral anticoagulants identified 960 hospitalizations with liver injury between 2011 and 2014, rates being highest for warfarin, intermediate for rivaroxaban, and lowest for apixaban and dabigatran; edoxaban was not included in the analyses having been approved for use in 2015).
Nagaoki Y, Aikata H, Daijyo K, Teraoka Y, Shinohara F, Nakamura Y, Hatooka M, et al. (2018). Efficacy and safety of edoxaban for treatment of portal vein thrombosis following danaparoid sodium in patients with liver cirrhosis. Hepatol Res. (Among 50 patients with cirrhosis and portal vein thrombosis treated with low molecular weight heparin followed by either warfarin or edoxaban for up to 6 months, portal vein thrombus reduction was greater with edoxaban and adverse event rates including gastrointestinal bleeding were similar; no mention of ALT elevations and there were no liver related severe adverse events).
Qamar A, Antman EM, Ruff CT, Nordio F, Murphy SA, Grip LT, Greenberger NJ, et al. (2019). Edoxaban versus warfarin in patients with atrial fibrillation and history of liver disease. J Am Coll Cardiol. (Among 21,105 adults enrolled in a randomized controlled trial of edoxaban [30 or 60 mg daily] versus warfarin, 1083 [5%] had a history of liver disease, and while rates of bleeding episodes were more frequent in those with than without liver disease, rates of stroke, myocardial infarction and suspected drug induced liver injury were similar in the two groups).
Björnsson HK, Gudmundsson DO, Björnsson ES. (2020). Liver injury caused by oral anticoagulants: A population-based retrospective cohort study. Liver Int. (Search of Icelandic National Prescription Databases and Health Records identified 3 cases of clinically apparent, acute liver injury in 3446 [0.1%] patients taking rivaroxaban, but in none of 9101 taking warfarin, or in 1903 taking apixaban, 1335 dabigatran or 34 edoxaban).
Yang X, Li N, Guo T, Guan X, Tan J, Gao X, Wu Y, Jia L, et al. (2020). Comparison of the effects of low-molecular-weight heparin and fondaparinux on liver function in patients with pulmonary embolism. J Clin Pharmacol. (Among 463 adults with pulmonary embolus treated with low molecular weight heparins or with fondaparinux, 79 [17%] developed evidence of liver injury that was generally mild and less than 3 times ULN in 98%, compared to 15% of 377 on edoxaban, 32% of 59 on nadroparin, and 7.4% of 27 on fondaparinux).
Zhao J, Blais JE, Chui CSL, Suh IH, Chen EYH, Seto WK, Mok MT, et al. (2020). Association between nonvitamin K antagonist oral anticoagulants or warfarin and liver injury: a cohort study. Am J Gastroenterol. (Among 13,698 patients with atrial fibrillation started on anticoagulant therapy and followed in the Hong Kong Clinical Database and Reporting system between 2010 and 2016, 513 [2.8%] developed evidence of liver injury and propensity matching indicated that liver injury was less frequent [2.1% vs 3.4%], although more severe with oral anticoagulants than with warfarin).
Maura G, Bardou M, Billionnet C, Weill A, Drouin J, Neumann A. (2020). Oral anticoagulants and risk of liver injury in patients with nonvalvular atrial fibrillation: a propensity-weighted nationwide cohort study. Sci Rep. (Among 434,015 patients with atrial fibrillation started on anticoagulant therapy and followed in the French National Healthcare Database, 218 [0.6%] were subsequently hospitalized for acute liver injury, the rates being similar for those on dabigatran [26 of 51,737 patients], apixaban [29 of 62,503 patients] and rivaroxaban [46 of 99,408 patients]).
Zhou J, Leung KSK, Kong D, Lee S, Liu T, Wai AKC, Chang C, et al. (2021). Low rates of liver injury in edoxaban users: Evidence from a territory-wide observational cohort study. Clin Cardiol. (Among 1213 patients with atrial fibrillation started on edoxaban between 2016 and 2020 and followed in the Hong Kong Clinical Database and Reporting System, 19 [1.5%] developed evidence of liver injury, a rate below that previously reported for warfarin [3.7%], apixaban [2.5%], and rivaroxaban [2.1%]).
De Caterina R, Kim YH, Koretsune Y, Wang CC, Yamashita T, Chen C, Reimitz PE, et al. (2021). Safety and effectiveness of edoxaban in atrial fibrillation patients in routine clinical practice: one-year follow-up from the Global Noninterventional ETNA-AF Program. J Clin Med. (Among 26,823 adults from Europe and Asia with atrial fibrillation enrolled in a postmarketing study of edoxaban, major complications were uncommon including annualized event rates of major bleeding episodes of 1.1%, strokes of 1.1%, cardiovascular mortality in 1.2% and all-cause mortality in 3%; rates of liver injury were not provided).
Ma J, Chalasani NP, Schwantes-An L, Björnsson ES. (2023). Review article: the safety of anticoagulants and antiplatelet agents in patients with cirrhosis. Aliment Pharmacol Ther. (Review of the safety of anticoagulant use in patients with cirrhosis mentions that drug induced liver injury is uncommon in patients with preexisting cirrhosis, at least in those with compensated [Child’s Class A] or mildly compensated [Child’s Class B] cirrhosis).

## OTHER REFERENCE LINKS

1 Recent References on Edoxaban: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Edoxaban+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Edoxaban: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Edoxaban)